# Aspirin

## OVERVIEW

### Introduction

Aspirin or acetylsalicylic acid is perhaps the most commonly used analgesic and antipyretic medication worldwide, having been in clinical use for over 100 years. Aspirin can cause several forms of liver injury: in high doses, aspirin can cause moderate to marked serum aminotransferase elevations occasionally with jaundice or signs of liver dysfunction, and in lower doses in susceptible children with a febrile illness aspirin can lead to Reye syndrome.

### Background

Aspirin is a salicylate, but technically is also a nonsteroidal antiinflammatory drug (NSAID). Like the NSAIDs, salicylates are inhibitors of tissue cyclooxygenases (Cox-1 and -2) which cause a decrease in synthesis of proinflammatory prostaglandins, potent mediators of pain and inflammation. In distinction to other NSAIDs, however, aspirin is a noncompetitive and irreversible inhibitor of Cox-1, so that its effects are longer lasting and less easily reversed than those of typical NSAIDs. Aspirin has potent effects in inhibiting platelet function that lasts for the lifetime of the platelet. Aspirin’s potent and lasting effects on Cox-1 in gastric epithelial cells account for its frequent gastric side effects and association with peptic ulcer disease and gastrointestinal bleeding. Aspirin is indicated for the treatment of mild to moderate pain from headaches, colds, arthritis, menstrual periods, toothaches and joint and muscle aches caused by trauma, osteoarthritis, or rheumatoid arthritis. Higher, more continuous doses of aspirin are effective in therapy of juvenile rheumatoid arthritis, systemic lupus erythematosus, rheumatoid arthritis, acute rheumatic fever and Kawasaki disease. Aspirin has antipyretic effects and can be used for management of fever, but should not be used in children or adolescents because of its potential to cause Reye syndrome. In low daily doses (81 mg), aspirin is used to decrease the risk of coronary and cerebrovascular disease and reocclusion after coronary revascularization or stent placement. Aspirin became clinically available in the United States in the early part of the 20th century and is currently widely used as an over-the-counter medication. It is available in multiple generic formulations, either alone or in combination with other pain relievers, antacids, or cough and cold medications. Aspirin is typically taken in doses of 330 to 660 mg every 4 to 6 hours. The dose used for antiplatelet effects in prevention of complications of atherosclerosis is 81 mg once daily. Common brand names for aspirin alone or in combination with other agents include Bayer’s Aspirin, Alka Seltzer, Anacin, Ascriptin, Aspergum, BC Powder, Bufferin, Ecotrin, Excedrin and Stanback.

### Hepatotoxicity

Patients on long term, moderate-to-high dose aspirin therapy frequently have elevations in serum ALT levels. With high doses, ALT elevations are common and can be marked and associated with mild increases in alkaline phosphatase and bilirubin. The more dramatic examples of aspirin hepatotoxicity usually occur with doses of 1,800 to 3,200 mg daily (>100 mg/kg) and with salicylate levels of greater than 25 mg/dL, but mild-to-moderate ALT elevations occur with even lower doses and lower serum levels. These abnormalities resolve rapidly with discontinuation of aspirin, but instances of resolution despite continuation of aspirin in the same or lower doses (adaptation) have also been described. The hepatotoxicity of aspirin is usually mild and asymptomatic, although with higher doses symptoms of nausea, anorexia and abdominal pain and even encephalopathy with signs of hepatic dysfunction (hyperammonemia and coagulopathy) can occur. Bilirubin elevations are usually mild or absent. Mild eosinophilia may accompany the enzyme elevations, but rash, fever and other allergic manifestations are rare. Liver biopsy histology generally shows minimal injury despite the height of the enzyme elevations; electron microscopy may reveal fat and mitochondrial abnormalities. Aspirin can often be continued in lower doses safely.

Likelihood score: A[HD] (well known cause of clinically apparent liver injury when given in high doses).

### Reye Syndrome

A special form of aspirin hepatotoxicity is Reye Syndrome, the development of lactic acidosis, microvesicular fat and hepatic dysfunction with encephalopathy and coma. Serum aminotransferase levels are usually markedly increased while serum bilirubin is minimally or only moderated elevated despite signs of hepatic failure such as hyperammonemia and encephalopathy. Reye syndrome usually occurs in children or young adults developing a few days to a week after a prodromal febrile illness, typically influenza B or varicella. It is often rapidly fatal, but in milder cases recovery is rapid. Reye syndrome was first reported in Australia in 1963, but subsequently was reported from around the world with increasing frequency and peaking in incidence in the 1970s and 1980s. Subsequently, case reports followed by careful epidemiological surveys linked the occurrence of Reye syndrome to receipt of aspirin during the prodromal viral illness. With medical recognition of this association, followed by wide scale public warnings, the use of aspirin in children with fever decreased markedly and the frequency of Reye syndrome fell dramatically. In the United States, reported cases of Reye syndrome fell from more than 500 cases per year before 1986 to less 2 cases per year thereafter. Occasional rare case reports of Reye syndrome still appear. Reye syndrome can also occur in adults.

### Mechanism of Injury

The association of hepatotoxicity with use of high doses of aspirin, short latency and linkage to high serum levels of salicylates suggest that aspirin is a direct, intrinsic hepatotoxin. Patients with severe hepatic reactions to aspirin can safely take acetaminophen or other NSAIDs, and usually tolerate lower doses of aspirin without problems. In the case of Reye syndrome, aspirin has been shown to inhibit mitochondrial function and the combination of a systemic viral illness with drug induced mitochondrial dysfunction is thought to underlie the pathogenesis of Reye syndrome. Other drugs that inhibit mitochondrial function (amiodarone, valproate, nucleoside analogues) can cause a similar clinical syndrome. The mitochondrial failure is manifested by Lactic Acidosis, acute microvesicular Steatosis and Hepatic dysfunction (LASH).

### Outcome and Management

Liver injury from high doses of aspirin is usually mild and self-limited. Symptoms attributable to liver injury (as opposed to the other side effects of aspirin itself) are common but generally nonspecific and mild. Typically, ALT elevations fall to normal within days of stopping. No convincing cases of acute liver failure or chronic liver injury or chronic vanishing bile duct syndrome due to aspirin have been published. Reye syndrome induced by aspirin, on the other hand, is a serious and potentially life threatening condition that should be managed with emergency intensive care. The mitochondrial failure of Reye syndrome is rapidly reversible and the major focus of management should be clinical support during the acute phase. Infusions of 20% glucose may help sustain hepatic and brain function during the temporary mitochondrial failure. Recurrence of Reye syndrome has been reported in children who have recovered and were then treated again with aspirin during an acute febrile illness. Children who require long term therapy with aspirin or other mitochondrial inhibitors should receive influenza and varicella vaccine and parents should be alert to the signs and symptoms of Reye syndrome.

Drug Class: Antithrombotic Agents, Antiplatelet Agents, Salicylates

Other Drugs in the Subclass, Antiplatelet Agents: Cangrelor, Clopidogrel, Dipyridamole, Prasugrel, Ticagrelor, Ticlopidine, Vorapaxar

Other Drugs in the Salicylates Class: Diflunisal, Salsalate, Trisalicylate

## CASE REPORTS

### Case 1. Acute enzyme elevations due to high dose aspirin therapy.

[Modified from: Wolfe JD, Metzger AL, Goldstein RC. Aspirin hepatitis. Ann Intern Med 1974; 80: 74-6. PubMed Citation (http://www.ncbi.nlm.nih.gov/pubmed/4810352)]

A 20 year old woman with systemic lupus erythematosus was treated with aspirin in doses of 4.8 grams per day. Her arthralgias improved, but 5 days after starting she noted the onset of tinnitus, anorexia, nausea, and abdominal discomfort. A serum salicylate level was 45 mg/dL (high) and serum enzyme levels were elevated (Table). Her liver was tender, but she was not jaundiced. Aspirin was stopped and her symptoms and enzyme abnormalities resolved within a few days. Aspirin was subsequently restarted at the same dose. She developed symptoms within 2 days and serum ALT levels began to rise. A liver biopsy showed spotty necrosis and inflammation without fat or chronic liver disease. Aspirin was stopped and she was later treated successfully with corticosteroids.

#### Key Points

Medication: | Aspirin (4.8 g daily)
Pattern: | Mixed (R=2.5)
Severity: | 1+ (enzyme elevations without jaundice)
Latency: | 5 days initially, 2 days on rechallenge
Recovery: | Rapid (7-10 days)
Other medications: | None mentioned

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | | 30 | 75 | Normal | Aspirin started: 4.8 g/day
5 | 0 | 168 | 197 | | Symptoms: salicylate level 45 mg/dL, aspirin stopped
7 | 2 | 175 | 205
10 | 5 | 55 | 180
12 | 7 | 30 | 96
18 (0) | 13 | 30 | 35 | | Aspirin restarted at 4.8 g/day
20(2) | | 100 | 105
21(3) | 0 | 300 | 205 | Normal | Liver biopsy: aspirin stopped
22(4) | 1 | 440 | 400
23(5) | 2 | 360 | 370
24(6) | 3 | 230 | 360
25(7) | 4 | 110 | 260 | | Discharged on prednisone
33(15) | 12 | 20 | 55
53(35) | 32 | 25 | 40
Normal Values | | <40 | <115 | <1.2

#### Comment

A very convincing case of aspirin induced hepatotoxicity. The onset of liver injury was within a few days of starting high doses of aspirin. The patient was mildly symptomatic but not jaundiced. There were also changes in alkaline phosphatase levels. Toxicity appeared to correlate with serum salicylate levels. Recovery was rapid once ASA was stopped and recurred when aspirin was restarted. Lower doses may have been tolerated without toxicity but were considered subtherapeutic for management of lupus. Liver biopsy showed minor nonspecific changes.

### Case 2. Reye syndrome in a child with juvenile rheumatoid arthritis.

[Modified from: Norman MG, Lowden JA, Hill DE, Bannayne RM. Encephalopathy and fatty degeneration of the viscera in childhood: II. Report of a case with isolation of influenza B virus. Canad Med Assoc J 1968; 99: 522-6. PubMed Citation (http://www.ncbi.nlm.nih.gov/pubmed/4300792)].

A 9 year old girl with juvenile rheumatoid arthritis on salicylates developed nausea, vomiting and drowsiness and was admitted to hospital for suspected salicylate intoxication. However, blood salicylate levels were within the therapeutic range (17.5/mg/dL) and she developed progressive restlessness, confusion and ultimately coma. She had acidosis and hypoglycemia and was treated with intravenous fluids. Serum AST levels were normal on admission but rose to 696 U/L, which led to an emergency liver biopsy that showed microvesicular fatty change with no inflammation, fibrosis or architectural distortion. The liver was devoid of glycogen. Despite supportive care and artificial ventilation she developed progressive coma, cerebral edema and died 72 hours after admission which was 5 days after initial symptoms of vomiting. Autopsy showed cerebral edema and steatosis in the liver with both macro- and microvesicular fat. Although there was no antecedent history of upper respiratory illness, she had complained of headaches for 2 weeks before onset and influenza B virus was isolated from the liver biopsy and from multiple tissues at autopsy.

#### Key Points

Medication: | Aspirin (salicylate levels maintained at 20-25 mg/dL)
Pattern: | Hepatocellular (acute fatty liver) (R=33)
Severity: | 5+ (death)
Latency: | 2 months from initiation of aspirin use, 1 day after onset of vomiting
Recovery: | None
Other medications: | Vitamins, throat lozenges and proprietary laxative

#### Laboratory Values

Days After Stopping | AST (U/L) | Alk P (KA U/L) | Arterial pH | Glucose (mg/dL) | Other
0 | | | 7.25 | | Serum salicylate levels 17.5 mg/dL
1 | 35 | 27 | 6.80 | 25 | IV fluids initiated, bilirubin 1.2 mg/dL
2 | 696 | 12 | 7.51 | 155 | Ventilatory support, liver biopsy
3 | 475 | | 7.43 | >200
4 | 4 | | | | Death from cerebral edema
Normal | <35 | <20 | 7.40 | 70-115

#### Comment

A well described case of Reye syndrome arising in a child on chronic salicylate therapy for juvenile rheumatoid arthritis. This case was described before epidemiological data linked Reye syndrome with influenza B and aspirin and is strikingly prescient. The initial symptoms were probably due to lactic acidosis, and AST levels rose shortly thereafter. In cases with recovery, aminotransferase levels fall as rapidly as they had risen. Initially, liver tissue shows microvesicular fat and absence of glycogen as the liver cell uses glycolysis to compensate for the lack of ATP produced by mitochondria. When this mechanism fails, lactic acid levels rise and hepatocytes release enzymes triggered by apoptosis from mitochondrial and cell functional failure. These processes occur rapidly, even before aminotransferase and bilirubin levels rise (the latter being a product of hepatocellular failure).

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acetylsalicylic Acid, Aspirin – Generic, Bayer Aspirin®

DRUG CLASS

Antithrombotic Agents, Antiinflammatory Agents, Salicylates

COMPLETE LABELING (not available)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Aspirin | 50-78-2 | C9-H8-O4

## ANNOTATED BIBLIOGRAPHY

References updated: 27 July 2017

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. Chapter 19: The NSAIDS. In Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott Williams & Williams, 1999, 599-602. (Review of hepatotoxicity of aspirin published in 1999 mentions two different forms of injury; the development of high ALT elevations with high doses of aspirin and Reye syndrome arising days to weeks after aspirin use in children with febrile illnesses).
Grossner T, Smyth EM, Fitzgerald GA. Anti-inflammatory, antipyretic, and analgesic agents: pharmacotherapy of gout. In, Brunton LL, Chabner BA, Knollman BC. Goodman & Gilman’s The pharmacological basis of therapeutics, 12th ed. New York: McGraw-Hill, 2011. p. 959-1004. (Textbook of pharmacology and therapeutics).
Manso C, Taranta A, Nydick I. (1956). Effect of aspirin administration on serum glutamic oxaloacetic and glutamic pyruvic transaminases in children. Proc Soc Exp Biol Med. (Study shortly after development of ALT and AST as tests for liver injury in 23 children convalescing from acute rheumatic fever, showed normal ALT levels before, but rises to 70-900 U/L after 1-2 weeks of salicylates in ~50% of children, rapid recovery).
Reye RD, Morgan G, Baral J. (1963). Encephalopathy and fatty degeneration of the viscera. A disease entity in childhood. Lancet. (Initial report of Reye syndrome: 21 children [<1 to 8 years old] seen at Royal Alexandra Hospital, Sydney Australia between 1951-62 with syndrome of upper respiratory illness for 1-3 days followed by abrupt deterioration with severe vomiting, agitation, stupor, convulsions and coma; hyperpnea and liver enlargement common; hypoglycemia and renal insufficiency common, ALT and AST raised and protime prolonged in those tested, autopsy in 17 cases showed cerebral edema but not herniation, enlarged liver with fatty change, but no necrosis or inflammation and no glycogen; may respond to glucose infusions; no toxin identified; mentions recent case reports by Curry and Anderson and similarity to Jamaican vomiting sickness; 81% mortality).
Okumura H, Takayama K, Obayashi K, Ichikawa T, Aramaki T. (1965). Nippon Rinsho. (Article in Japanese: case report followed by prospective study of 15 patients given aspirin [2 g/day] for 4 weeks with monitoring of liver tests: ALT levels rose in 5 to as high as 150 U/L with no change in bilirubin or BSP retention; occasional rise in Alk P levels).
Norman MG. (1968). Encephalopathy and fatty degeneration of the viscera in childhood: I. Review of cases at the Hospital for Sick Children, Toronto (1954-1966). Can Med Assoc J. (21 cases, prodrome of 4 days of upper respiratory illness, followed by vomiting, confusion, convulsions and quiet drift into coma, 50% mortality within 24 hours; hypoglycemia and acidosis frequent, AST 700-1400 U/L, histology showed small fat droplet change).
Norman MG, Lowden JA, Hill DE, Bannayne RM. (1968). Encephalopathy and fatty degeneration of the viscera in childhood: II. Report of a case with isolation of influenza B virus. Can Med Assoc J. (Case report of child with juvenile rheumatoid arthritis on salicylates who developed Reye syndrome in whom influenza B virus was isolated from liver biopsy and autopsy tissue; AST initially normal [35 U/L] when presenting with acidosis and hyperventilation, later rising to 696 U/L just before death, 5 days after onset: Case 2).
Russell AS, Sturge RA, Smith MA. (1971). Serum transaminases during salicylate therapy. Br Med J. (Nine of 33 children with chronic aspirin therapy developed high ALT levels, almost all with salicylate levels above 35 mg/dL, mild Alk P elevations in 3 patients).
Lee-Jones M. (1971). Serum transaminases during salicylate therapy. Br Med J. (Letter in response to Russell [1971], found AST elevations in only 1 of 16 adults with acute salicylate overdose and serum levels >35 mg/dL).
Iancu T. (1972). Serum transaminases and salicylate therapy. Br Med J. (Normal ALT and AST levels were found in 41 children with rheumatic fever on admission; but 10 of 14 receiving aspirin had ALT elevations of 51-300 U/L, usually with salicylate levels >30 mg/dL arising in 10-20 days, rapidly resolving with stopping, normal bilirubin; occasionally raised Alk P level).
Athreya BH, Gorske AL, Myers AR. (1973). Aspirin-induced abnormalities of liver function. Am J Dis Child. (Child with juvenile rheumatoid arthritis with elevations in ALT during three courses of aspirin; first exposure, ALT 310 U/L and resolution in 7 days; 2nd exposure, ALT 180 U/L and biopsy showed minimal changes; 3rd exposure, ALT 700 U/L, Alk P 400 U/L, bilirubin 2.4 mg/dL with resolution requiring 60 days).
Mowat AP. (1973). Encephalopathy and fatty degeneration of viscera: Reye's syndrome. Arch Dis Child. (Early review of the histologic features of Reye syndrome: "The liver at necropsy is swollen and tense, orange to pale yellow in colour, the cut surface being relatively bloodless, greasy, and firm; in liver biopsy specimens fatty infiltration is seen as diffuse small vacuoles most prominent in the periportal areas, but there is massive fatty infiltration in necropsy material").
Rich RR, Johnson JS. (1973). Salicylate hepatotoxicity in patients with juvenile rheumatoid arthritis. Arthritis Rheum. (6 patients with juvenile rheumatoid arthritis treated at the NIH with high doses of salicylates [>25 mg/dL]; high serum levels associated with nausea and anorexia and ALT elevations [100-1800 U/L] and lesser increases in Alk P and eosinophils [from 90, 94, 70, 310, 400 and 175 /μL to 440, 945, 924, 570, 4900, and 485/μL]).
(1973). Liver injury by salicylates. Br Med J. (Editorial discussing results of Rich and Johnson [1973]).
Gitlin N, Dietrich B, Spektor F. (1974). Salicylate hepatitis. A case report. S Afr Med J. (14 year old with juvenile rheumatoid arthritis given 3 to 10 g/day of Disprin [a salicylate] developed fever, rash and eosinophilia with ALT 700 U/L, bilirubin 2.1 mg/dL, Alk P ~1.5 times ULN; rechallenge caused recurrence in 2 days with 38% eosinophils, biopsy showed hepatitis and stellate fibrosis, recovery in <7 days).
Iancu T, Elian E. (1974). Letter: Aspirin-induced abnormalities of liver function. Am J Dis Child. (Letter in response to Athreya [1973] reminding the authors of their publication in BMJ [1972]).
Koppes GM, Arnett FC. (1974). Salicylate hepatotoxicity. Postgrad Med. (Young man with suspected juvenile rheumatoid arthritis developed AST 2,200 U/L, protime 16 seconds after 2 weeks of aspirin [5.85 g/day, levels >25 mg/dL], biopsy showed acidophilic bodies and mild inflammation; no symptoms, rapid resolution).
Prinsloo JG. (1974). Letter: Salicylate toxicity. S Afr Med J. (Letter regarding article by Gitlin [1974], arguing against use of high dose aspirin in children).
Seaman WE, Ishak KG, Plotz PH. (1974). Aspirin-induced hepatotoxicity in patients with systemic lupus erythematosus. Ann Intern Med. (3 patients with systemic lupus given ASA found to have asymptomatic ALT and AST elevations, but no jaundice; ALT 378, 670, 830 U/L at 6-8 days, recovery in <7 days; biopsy in 2 showed minimal changes, occasional ballooned cell, scattered foci of inflammation and necrosis and acidophilic bodies).
Goldenberg DL. (1974). Letter: Aspirin hepatotoxicity. Ann Intern Med. (Letter in response to article by Seaman [1974], reporting case of aspirin hepatotoxicity in 16 year old with systemic lupus, given aspirin [2.4 g/day] for 10 days with AST 540 U/L, Alk P 150 U/L, salicylates 11 mg/dL: ALT remaining elevated for further 6 months and rising to >1000 U/L when switched to choline salicylate, resolving within 10 days of stopping).
Hilton AM, Dymock IW. (1974). Letter: Aspirin hepatotoxicity. Ann Intern Med. (Letter in response to article by Seaman [1974] suggesting that mild, underlying chronic liver disease is common in lupus and may account for ALT elevations).
Seaman WE, Ishak KG, Plotz PH. (1974). Letter: Aspirin and hepatotoxicity. Ann Intern Med. (Reply to Hilton [1974], mentioning that re-biopsy of patient with aspirin hepatotoxicity 18 months later showed no chronic liver disease, but rather minimal, nonspecific changes).
Wolfe JD, Metzger AL, Goldstein RC. (1974). Aspirin hepatitis. Ann Intern Med. (Young patient with lupus was given aspirin [4.8 g/day for 5 days] and developed symptoms of anorexia and nausea [no jaundice, ALT 168 U/L, Alk P 197], resolving in 12 days: rechallenge caused recurrence in 2 days [ALT 300 U/L] and biopsy showed minimal changes: Case 1).
Zimmerman HJ. (1974). Editorial: Aspirin-induced hepatic injury. Ann Intern Med. (Editorial accompanying article by Seaman [1974] makes point of high dose aspirin being a direct hepatotoxin, causing self-limited, rapidly resolving hepatocellular injury; 3-5 g/day yielding serum levels ~20 to 45 mg/dL [2-5 mM], a level rarely reached by other drugs).
Athreya BH, Moser G, Cecil HS, Myers AR. (1975). Aspirin-induced hepatotoxicity in juvenile rheumatoid arthritis. A prospective study. Arthritis Rheum. (ALT, AST or Alk P elevations occurred in 22 of 34 children with juvenile rheumatoid arthritis on aspirin, usually mild, correlating poorly with dose and serum levels, some resolving despite continuation of aspirin; no mention of bilirubin or symptoms).
Bar-Meir S, Papa MZ. (1975). Harefuah.
Garber E, Craig RM, Bahu RM. (1975). Letter: Aspirin hepatotoxicity. Ann Intern Med. (Case of aspirin liver injury in patient without rheumatologic disorder taking 8 g/day of aspirin for headaches [ALT 111 U/L, Alk P 108 U/L], liver biopsy showing focal necrosis and inflammation, resolving within 7 days of stopping).
Linnemann CC, Shea L, Partin JC, Schubert WK, Schiff GM. (1975). Reye's syndrome: epidemiologic and viral studies, 1963-1974. Am J Epidemiol. (Study of 58 children with Reye syndrome: 3 had recurrence; 6 occurred after chickenpox, but most after influenza B; 36% mortality, average symptoms for 7 days, 91% took salicylates, 88% had positive salicylate levels).
Sillanpää M, Mäkelä AL, Koivikko A. (1975). Acute liver failure and encephalopathy (Reye's syndrome?) during salicylate therapy. Acta Paediatr Scand. (13 year old with fever and joint aches given salicylates, developed upper respiratory infection followed by confusion and coma [bilirubin 1.4 mg/dL, AST 2500 U/L], with rapid recovery and no recurrence of arthritis; no liver biopsy and unclear whether it was acute salicylate toxicity or Reye syndrome).
Daum F, Zucker P, Cohen MI. (1976). Acute liver failure and encephalopathy (Reye's syndrome?) during salicylate therapy. Acta Paediatr Scand. PubMed Citation (Letter in response to article by Sillanpaa [1975] suggesting that liver biopsy is necessary for diagnosis of Reye syndrome).
Zucker P, Daum F, Cohen MI. (1975). Aspirin hepatitis. Am J Dis Child. (Two children on high dose aspirin [2.4-3.6 g/day] developed abdominal pain and AST elevations [400 and 1290 U/L], resolving with stopping, positive rechallenge in one; review of literature).
Levy G, Yaffe SJ. (1975). Clinical implications of salicylate-induced liver damage. Am J Dis Child. (Comment in response to article by Zucker [1975], suggesting monitoring and dose adjustment when using aspirin).
Athreya BH. (1976). Letter: Aspirin hepatitis. Am J Dis Child. (Letter in response to Zucker [1975] mentioning their publication [Athreya 1973]).
Barone R, Chase PH, Wallace SL. (1976). Letter: Salicylate-induced hepatic injury. Arthritis Rheum. (Elderly woman given aspirin [3 g/day] for fractured ankle developed ALT elevations [20 rising to 402 U/L] after 12 days, resolving in 12 days, with positive rechallenge [salicylate levels ~25 mg/dL]).
Halla JT. (1976). Aspirin, liver, and rheumatic diseases. J Med Assoc State Ala.
Iancu T, Elian E. (1976). Ultrastructure changes in aspirin hepatotoxicity. Am J Clin Path. (Electron microscopy of liver biopsy from child with rheumatic fever with ALT elevations [240 U/L] on aspirin: marked ER dilation, pleomorphic mitochondria with increased density and fat droplets).
Miller JJ, Weissman DB. (1976). Correlations between transaminase concentrations and serum salicylate concentration in juvenile rheumatoid arthritis. Arthritis Rheum. (Among 92 children with juvenile rheumatoid arthritis, 41% had ALT and 59% AST elevations on aspirin; usually mild; poor correlation with serum salicylate levels, dose or duration of therapy; biopsy in one showed minor nonspecific changes).
Rachelefsky GS, Kar NC, Coulson A, Sarkissian E, Stiehm ER, Paulus HE. (1976). Serum enzyme abnormalities in juvenile rheumatoid arthritis. Pediatrics. (Mild and fluctuating ALT and AST elevations found in 37 children with juvenile rheumatoid arthritis without apparent correlation with aspirin use or levels, but dose unclear and not prospectively designed study or analysis).
Ricks WB. (1976). Letter: Salicylate hepatotoxicity in Reiter's syndrome. Ann Intern Med. (18 year old man with Reiter syndrome developed rising AST levels [150 to 1200 U/L] while on aspirin [3.6 g daily], which fell rapidly to normal upon stopping and rose again [~350 U/L] within a few days of restarting; liver biopsy showed minimal inflammation and focal areas of necrosis).
Schulman P. (1976). Letter: Salicylate hepatotoxicity and HL-A-W27. Ann Intern Med. (Letter in response to Ricks [1976] asking whether HLA-W27 was tested in patient with Reiter syndrome; the author replies "no").
Saltzman DA, Gall EP, Robinson SF. (1976). Aspirin-induced hepatic dysfunction in a patient with adult rheumatoid arthritis. Am J Dig Dis. (Case report of adult with rheumatoid arthritis who developed ALT elevations during aspirin therapy with two positive rechallenges, latency of 5-7 days and peak ALT ~400 U/L without jaundice; liver biopsies showing cellular unrest; possibly microvesicular fat).
Seaman WE, Plotz PH. (1976). Effect of aspirin on liver tests in patients with RA or SLE and in normal volunteers. Arthritis Rheum. (Prospective study of 20 patients with rheumatoid arthritis, 16 with lupus and 3 normal volunteers: ALT elevations occurred in 20%, 44% and 33% after 2 weeks; levels being earlier and higher in lupus patients; no difference in albumin levels; hepatomegaly occurred in some and BUN and creatinine elevations in others).
Wilson JR. (1976). Aspirin hepatotoxicity in adults with rheumatoid arthritis. Ohio State Med J. (2 adult patients with rheumatoid arthritis had ALT elevations [590 and 229 U/L] with no symptoms after few weeks of high dose aspirin therapy [3.6 g/day], having previously tolerated lower doses without ALT elevations).
Bernstein BH, Singsen BH, King KK, Hanson V. (1977). Aspirin-induced hepatotoxicity and its effect on juvenile rheumatoid arthritis. Am J Dis Child. (Among 102 children with juvenile rheumatoid arthritis on aspirin, 5% had elevations in ALT [91% when tested serially], usually mild and self-limited, correlating poorly with dose and salicylate levels; excellent example of adaptation).
Fong WL, Wong PO, Rosenthal HL. (1977). Aspirin hepatotoxicity: case report. Drug Intell Clin Pharm. Not in PubMed
Gitlin N, Grant J. (1977). Raised serum transaminase levels in patients with rheumatic fever treated with salicylates. S Afr Med J. (11 children with acute rheumatoid fever given aspirin and followed for AST and salicylate levels; 6 had AST elevations of 20-505 U/L [only with salicylate levels >19.2 mg/dL] and 10 had eosinophilia >600/μL; all asymptomatic).
O'Gorman T, Koff RS. (1977). Salicylate hepatitis. Gastroenterology. (2 patients with ALT elevations [250 and 1000 U/L] arising after 4 and 7 days of aspirin therapy [5.2 and 2.4 g/day] for rheumatoid arthritis and lupus; biopsies showed lobular disarray and occasional spotty necrosis; rapid recovery).
O'Gorman T, Koff RS. (1978). Wien Med Wochenschr. (German translation of same article).
Sbarbaro JA, Bennett RM. (1977). Aspirin hepatotoxicity and disseminated intravascular coagulation. Ann Intern Med. (17 year old with juvenile rheumatoid arthritis developed ALT elevations [>500 U/L, bilirubin 3.0 mg/dL] on aspirin with positive rechallenge and microangiopathic anemia).
Babb RR. (1978). Analgesic hepatotoxicity. West J Med. (Editorial on aspirin and acetaminophen hepatotoxicity without new information).
Boss G. (1978). Internal Medicine-Epitomes of Progress: Hepatotoxicity caused by acetaminophen or salicylates. West J Med. (Editorial pointing out that chronic high dose salicylate therapy rather than acute overdose leads to hepatotoxicity).
Bryant CE. (1978). Salicylate-induced hepatotoxicity: a review. J Okla State Med Assoc. (Review article without new information).
Jespersen J. (1978). Ugeskr Laeger.
Kanada SA, Kolling WM, Hindin BI. (1978). Aspirin hepatotoxicity. Am J Hosp Pharm. (After 11 days of aspirin [3.6-4.8 g/day], 46 year old man developed elevated AST levels [rising from 15 to 160 to 350 U/L] without rise in bilirubin, and return to normal 8 days after switching to ibuprofen).
Knudsen FU. (1978). Ugeskr Laeger.
Mesihović H. (1978). Med Arh. (Among 199 patients with rheumatic disorders, 6 [3%] had raised ALT [44-485 U/L] or AST [60-400 U/L] compared to 12 of 26 [46%] children with juvenile rheumatoid arthritis [ALT 438-296 U/L], arising 1-22 weeks after starting salicylates).
Petty BG, Zahka KG, Bernstein MT. (1978). Aspirin hepatitis associated with encephalopathy. J Pediatr. (Child with lupus given aspirin [70 mg/kg/day] developed lethargy after 5 days, followed by nausea and disorientation with ALT 340 U/L, bilirubin 0.8 mg/dL, abnormal EEG, liver biopsy showing mild injury and inflammation; rapid resolution, positive rechallenge).
Schaller JG. (1978). Chronic salicylate administration in juvenile rheumatoid arthritis: aspirin "hepatitis" and its clinical significance. Pediatrics. (Review article on salicylates, including hepatotoxicity and 3 case reports, including one with juvenile rheumatoid arthritis and liver disease independent of aspirin and two patients who demonstrated sensitivity to the hepatotoxicity of aspirin).
Travers RL, Hughes GR. (1978). Salicylate hepatotoxicity in systemic lupus erythematosus: a common occurrence?. Br Med J. (7 patients with systemic lupus or connective tissue disorder on aspirin [1.8-3.6 g daily] had AST elevations of 160-300 U/L, all asymptomatic, none jaundiced, all resolving within 10 days of stopping).
Ulshen MH, Grand RJ, Crain JD, Gelfand EW. (1978). Hepatotoxicity with encephalopathy associated with aspirin therapy in rheumatoid arthritis. J Pediatr. (3 children with juvenile rheumatoid arthritis developed encephalopathy after 1-3 weeks of aspirin therapy [100-200 mg/day] with AST 1089-5600, bilirubin 2.2-4.7 and salicylate levels >35 mg/dL, with several recurrences on rechallenge, rapid recoveries; liver biopsy in 2 patients showed minimal changes and no mention of microvesicular fat).
Bulugahapitiya DT, Hebron B, Beck PR. (1979). Salicylate hepatitis with acidosis in an infant. Lancet. (7 month old developed acidosis [pH 7.35 and 7.2] and ALT elevations [169 and 543 U/L] after being given aspirin for 5-7 days twice; ammonia elevated but no encephalopathy).
Jespersen J, Ejstrup L. (1979). Ugeskr Laeger.
Lahaie RG, Blondin C, Huet PM. (1979). Salicylate hepatitis in a case of juvenile dermatomyositis. Can Med Assoc J. (Child with dermatomyositis developed nausea and ALT elevations after 2 days of aspirin [ALT 600 U/L, bilirubin 1.2 mg/dL], with positive rechallenge and biopsy showing nonspecific changes).
Rochanawutanon M, Bunyaratvej S, Israngkura P. (1979). Salicylate induced hepatotoxicity in juvenile rheumatoid arthritis--a case report. J Med Assoc Thai. (7 year old girl with juvenile rheumatoid arthritis on aspirin and corticosteroids for ~5 months developed fever, rectal bleeding and jaundice, and died after unsuccessful surgery and complications; role of aspirin vs sepsis-shock unclear).
Carneskog J, Florath-Ahlmen M, Olsson R. (1980). Prevalence of liver disease in patients taking salicylates for arthropathy. Hepatogastroenterology. (Survey of 110 patients with arthritis treated with long term salicylates: 2 with minor ALT elevations and 9 with Alk P increases, but not clearly related to aspirin).
Gitlin N. (1980). Salicylate hepatotoxicity: the potential role of hypoalbuminemia. J Clin Gastroenterol. (Among 17 children with acute rheumatoid fever given salicylates [2.4-3.6 g/day], 9 [53%] developed asymptomatic AST elevations [25-270 U/L] directly related to salicylate levels [>15], but also inversely related to albumin suggesting role of free salicylate levels).
Mäkelä AL, Lang H, Korpela P. (1980). Toxic encephalopathy with hyperammonaemia during high-dose salicylate therapy. Acta Neurol Scand. (Two case reports of encephalopathy, hyperammonemia and AST elevations arising during high dose aspirin therapy of rheumatic disease in 8 and 13 year old children, both recovered; possibly Reye syndrome; 13 year old previously reported by Sillanpaa [1975]).
Mastaglia GL. (1980). Salicylate hepatotoxicity in rheumatoid arthritis. Med J Aust. (56 year old woman with rheumatoid arthritis given aspirin [3.9 g/day] developed asymptomatic AST elevations [800 U/L], resolving on stopping).
Bertino JS, Willis ED, Reed MD, Speck WT. (1981). Salicylate hepatitis: a complication of the treatment of Kawasaki's disease. Am J Hosp Pharm. (7 week old child with Kawasaki disease given aspirin [100 mg/kg/day] who developed rising AST levels [~1200 U/L] after 2 weeks, falling to normal with 7 days of stopping and remaining normal during lower dose therapy [30 mg/kg/day]).
Chesta J, Orellana Alcalde JM, Mehana D. (1981). Rev Med Chil.
Zimmerman HJ. Effects of aspirin and acetaminophen on the liver. Arch Intern Med 1981; 141 (3 Spec No): 333-42. (Summary of 320 reported patients with juvenile rheumatoid arthritis, rheumatic fever, systemic lupus, rheumatoid arthritis and other rheumatic and nonrheumatic conditions who developed hepatoxicity from aspirin; injury was characterized by mild symptoms, marked ALT and AST elevations with bilirubin elevations in only 3% and modest Alk P increases; some cases were severe with coagulopathy and rarely fatal; may be more common in children and possibly in juvenile rheumatoid arthritis, lupus and acute rheumatic fever than in other conditions; the injury probably represents intrinsic toxicity from aspirin).
Halpin TJ, Holtzhauer FJ, Campbell RJ, Hall LJ, Correa-Villaseñor A, Lanese R, Rice J, Hurwitz ES. (1982). Reye's syndrome and medication use. JAMA. (Analysis of medication exposure in 97 cases of Reye syndrome and 156 controls from 1978-80, among 90 medications reported, only aspirin differed between groups: 97% vs 71%).
von Mühlendahl KE. (1982). Dtsch Med Wochenschr. (Five children with juvenile rheumatoid arthritis given aspirin [46-100 mg/kg/day] developed ALT elevations of 185-1020 U/L after 17-25 days of therapy; bilirubin and Alk P were normal; resolved in 5-7 days, minimal or no symptoms).
Partin JS, Partin JC, Schubert WK, Hammond JG. Serum salicylate concentrations in Reye’s disease: a study of 130 biopsy-proven cases. Lancet 1982; 1 (Jan 23): 191-4. (Serum salicylate levels averaged 15 mg/dL in cases of Reye syndrome but averaged <2 mg/dL in controls; levels did not correlate well with severity of injury; no mention of what proportion of cases had detectable levels).
Schmidt RE. (1982). Dtsch Med Wochenschr.
Waldman RJ, Hall WN, McGee H, Van Amburg G. (1982). Aspirin as a risk factor in Reye’s syndrome. JAMA. (Case control study of 25 children with Reye syndrome and 46 controls found aspirin taken in 96% vs 74%).
Benson GD. (1983). Hepatotoxicity following the therapeutic use of antipyretic analgesics. Am J Med. (Review of hepatotoxicity of aspirin and acetaminophen when used in therapeutic doses recommends use of acetaminophen in patients with preexisting liver disease).
Hamdan JA, Ahmad MS, Sa'di AR. (1983). Salicylate hepatotoxicity in rheumatic fever. Ann Trop Paediatr. (Two children with acute rheumatic fever developed symptoms and AST elevations [1650 and 1325 U/L] with normal bilirubin after 12-13 days of aspirin therapy [100 mg/kg/day], resolving with lower doses).
Starko KM, Mullick FG. (1983). Hepatic and cerebral pathology findings in children with fatal salicylate intoxication: further evidence for a causal relation between salicylate and Reye's syndrome. Lancet. (Study of 13 children with salicylate intoxication from AFIP files, showing microvesicular fat in liver [usually mild and zone 1] and brains often showed cerebral edema).
Bhabha FS, Kshirsagar NA, Pohujani S, Dastur P, Joshi MU, Kandoth P, Satoskar RS. (1984). Effect of aspirin on renal and hepatic function in children suffering from juvenile rheumatoid arthritis and rheumatic fever. Indian J Pediatr. (24 children with juvenile rheumatoid arthritis or rheumatic fever studied prospectively during aspirin therapy [100 mg/kg/day] for 3 weeks; decline in creatinine clearance was common and 3 had asymptomatic ALT elevations [79, 146 and 300 U/L] returning to normal rapidly with stopping).
Partin JS, Daugherty CC, McAdams AJ, Partin JC, Schubert WK. (1984). A comparison of liver ultrastructure in salicylate intoxication and Reye's syndrome. Hepatology. (Liver biopsies from two children with aspirin hepatotoxicity showed minimal changes by electron microscopy with none of the mitochondrial enlargement or marked microvesicular fat seen in Reye syndrome despite similar ALT values).
Young RSK, Torretti D, Williams R, Hendriksen D, Woods M. (1984). Reye's syndrome associated with long-term aspirin therapy. JAMA. (Two cases and review of literature on Reye syndrome in children on long term aspirin for rheumatologic disorders; 3 and 1 year olds on 80 and 150 mg/kg/day of aspirin for 3 months developed fever and then vomiting and coma with AST 1532 and 3460 U/L, bilirubin 0.7 and 1.0 mg/dL and high ammonia, lactate and protime, both recovered but one left with spastic quadriparesis).
Hamdan JA, Manasra K, Ahmed M. (1985). Salicylate-induced hepatitis in rheumatic fever. Am J Dis Child. (Retrospective study of 34 Saudi children with rheumatic fever given salicylates; 5 had ALT elevations [216-1650 U/L], all with salicylate levels >25 mg/dL, rapid resolution, no jaundice but some with symptoms; managed with lower doses).
Hansen JR, McCray PB, Bale JF, Corbett AJ, Flanders DJ. (1985). Reye syndrome associated with aspirin therapy for systemic lupus erythematosus. Pediatrics. (14 year old on aspirin for 2 weeks developed fever, malaise and then stupor with AST 2130 U/L, bilirubin 0.8 mg/dL, high protime and ammonia levels with nontoxic salicylate levels; recovered slowly and redeveloped signs of lupus with stopping aspirin; biopsy showed mild microvesicular fat).
Everson GW, Krenzelok EP. (1986). Chronic salicylism in a patient with juvenile rheumatoid arthritis. Clin Pharm. (Case report of child with juvenile rheumatoid arthritis treated with aspirin [150 mg/day] developing lethargy, fever and rash progressing to disorientation: salicylate 44.2 mg/dL, ALT 1136 U/L, ammonia 186 μmol/L, bilirubin 2.1 rising to 10.8 mg/dL, protime 29 seconds; recovery in 2 weeks).
Jakubowska D, Grzebieniak-Kopieczna E. (1986). Wiad Lek.
Peters LJ, Wiener GJ, Gilliam J, Van Noord G, Geisinger KR, Roach ES. (1986). Reye's syndrome in adults: a case report and review of the literature. Arch Intern Med. (61 year old with febrile illness, took aspirin and 4 days later developed nausea, then confusion and admission for coma 2 days later, ALT 864 U/L, bilirubin and INR normal, liver biopsy showed microvesicular fat, rapid recovery; reviewed 11 cases of Reye syndrome in adults in literature: ages 18-51, receiving aspirin after upper respiratory illness, 3 died).
Cersosimo RJ, Matthews SJ. (1987). Hepatotoxicity associated with choline magnesium trisalicylate: case report and review of salicylate-induced hepatotoxicity. Drug Intell Clin Pharm. (Patient with lupus given trisalicylate [1.5 g/day] and in 3 days had rising ALT [711 U/L] and Alk P [376 U/L] but normal bilirubin, resolving rapidly with stopping: review of literature).
Grigor RR, Spitz PW, Furst DE. (1987). Salicylate toxicity in elderly patients with rheumatoid arthritis. J Rheumatol. (Analysis of ARAMIS system on 544 patients on salicylates alone in 3 age groups; elderly reported fewer side effects but used lower doses; liver toxicity not mentioned).
Heubi JE, Partin JC, Partin JS, Schubert WK. (1987). Reye's syndrome: current concepts. Hepatology. (Extensive review of the history, epidemiology, pathogenesis, etiology, role of salicylates, similarity to inborn errors of metabolism, and animal models of Reye syndrome).
Hurwitz ES, Barrett MJ, Gunn WJ, Pinsky P, Schonberger LB, Drage JS, et al. (1987). Public Health Service Study of Reye's syndrome and medications: report of the main study. JAMA. (Final analysis of prospective, case-control study of 27 patients with Reye syndrome presenting between 1985-6 and 140 controls showing salicylate use in 96% of cases vs 32% controls, odds ratio=40, doses of aspirin were not excessive, 90% had history of a preceding respiratory tract infection).
Freeland GR, Northington RS, Hedrich DA, Walker BR. (1988). Hepatic safety of two analgesics used over the counter: ibuprofen and aspirin. Clin Pharmacol Ther. (Analysis of database on 1468 patients with rheumatoid arthritis, including 439 given aspirin [2.6-3.9 g/day] found AST elevations in 4% to 22%; 10 patients had ALT >3 times ULN [2%], ibuprofen had lowest rate, oxaprozin intermediate).
Porter JDH, Robinson PH, Glasgow JFT, Banks JH., Hall SM. (1990). Trends in the incidence of Reye's syndrome and the use of aspirin. Arch Dis Child. (British Surveillance System data showed a marked decrease in use of aspirin in children with fever after public warning in 1986 and that the frequency of Reye syndrome subsequently declined from peak of 79 cases in 1983-4 to 19 in 1988-9).
De Leeuw P, Lefebvre C, Tomasi JP, Rahier J, Geubel A. (1992). Gastroenterol Clin Biol. (62 year old woman with systemic lupus on long term therapy with aspirin, had dose increased to 3.5 g/day and 10 days later developed weakness and confusion with ALT 34 times ULN, Alk P 2.9 times ULN, bilirubin 15.8 mg/dL, high ammonia; biopsy did not show microvesicular fat; resolved on low dose prednisone).
Nadkarni MM, Peller CA, Retig J. (1992). Eosinophilic hepatitis after ingestion of choline magnerium trisalicylate. Am J Gastroenterol. (66 year old woman with osteoarthritis took 3 days of trisalicylate and developed jaundice 3 days later with ALT 774 U/L, Alk P 542 U/L, bilirubin 14.3 mg/dL; 32% eosinophils, mild encephalopathy, but ultimate recovery; had a history of penicillin allergy).
Peraf F, Kovacs T, Jothy S. (1992). Syndrome de Reye de l'adulte. Gastroenterol Clin Biol. (24 year old with history of fever followed by somnolence had taken aspirin in unknown amounts and developed coma with ammonia 138 μmol/L, ALT 64 times ULN, Alk P <1 times ULN and bilirubin 1.5 mg/dL, with eventual rapid recovery).
Singh H, Chugh JC, Shembesh AH, Ben-Musa AA, Mehta HC. (1992). Hepatotoxicity of high dose salicylate therapy in acute rheumatic fever. Ann Trop Paediatr.
Chan ED. (1993). Reye's syndrome in a young adult. Mil Med. (26 year old woman with a 4 day history of cough and fever developed confusion, [bilirubin 0.8 mg/dL, ALT 683 U/L, ammonia 192 μmol/L, elevated lactic acid] and died within 2 weeks, with autopsy showing microvesicular fatty liver).
López-Morante AJ, Sáez-Royuela F, Díez-Sánchez V, Martín-Lorente JL, Yuguero L, Ojeda C. (1993). Aspirin-induced cholestatic hepatitis. J Clin Gastroenterol. (72 year old man with stroke developed cholestatic jaundice after 1 month of low dose aspirin [bilirubin 11.5 mg/dL, ALT 211 U/L, Alk P 646 U/L] with normal ERCP, no other drug exposure, resolving in 10 weeks off of aspirin).
Mallet EC, Gestas P, Vic P, Arnaud JP. (1993). Arch Fr Pediatr. (5 year old child with acute arthritis placed on aspirin [100 mg/kg/day] and developed confusion, nausea and vomiting 4 days later with subsequent fatal course [ALT 1230 U/L, pH 7.26, high ammonia and lactate but normal bilirubin], liver biopsy showing microvesicular fat).
Rubie H, Guillot S, Netter JC, Le Tallec C, Voigt JJ, Claeyssens S, Olives JP, et al. (1994). Arch Pediatr. (3 children developed Reye-like syndrome 1-2 months after course of chemotherapy of leukemia with acute encephalopathy, ALT elevations [2.5 to 4.5 times ULN], no jaundice, but microvesicular fat on liver biopsy; no history of aspirin use but one had prodromal febrile illness).
Sizykh TP, Efimova NIu. (1994). Probl Tuberk.
Hardie RM, Newton LH, Bruce JC, Glasgow JF, Mowat AP, Stephenson JB, Hall SM. (1996). The changing clinical pattern of Reye's syndrome: 1982-1990. Arch Dis Child. (Application of a scoring system for 445 cases of Reye syndrome showed that cases were fewer as well as milder after 1986).
Belay ED, Bresee JS, Holman RC, Khan AS, Shahriari A, Schonberger LB. (1999). Reye's syndrome in the United States from 1981 through 1997. N Engl J Med. (National Surveillance Data from 1980-97 of Reye syndrome in children <18 years showed a sharp decline with recognition of role of aspirin [1980], Surgeon General's advisory [1982] and aspirin labeling [1986], from peak of 555 cases in 1980 to <37 in 1987-93, to <2 in 1994-7: the case fatality rate was 31%).
Singh H, Chugh JC. (1999). Hepatotoxicity of salicylate therapy in acute rheumatic fever. Indian Pediatr. (Letter regarding review article on aspirin for rheumatic fever pointing out their results [Singh 1992]).
Caksen H, Guler E, Alper M, Ustunbas HB. (2001). A fatal case of Reye syndrome after varicella and ingestion of aspirin. J Dermatol. (4 year old with varicella treated with aspirin developed stupor one week later [ALT 150 U/L, ammonia 853 μmol/L, protime 27 seconds, and acidosis], and died within 3 days: microvesicular fat on autopsy).
Chen TC, Ng KF, Jeng LB, Yeh TS, Chen CM. (2001). Aspirin-related hepatotoxicity in a child after liver transplant. Dig Dis Sci. (4 year old child with biliary atresia, developed CMV infection after liver transplantation and was treated with aspirin for fever [Tapal 100 mg three times daily], developing ALT flare to 459 U/L, resolving within 20 days of stopping aspirin).
McGovern MC, Glasgow JF, Stewart MC. (2001). Lesson of the week: Reye's syndrome and aspirin: lest we forget. BMJ. (Two cases of Reye syndrome in children who took aspirin during febrile illnesses [AST 1113 and 1034 U/L, ammonia 181 and 108 μmol/L and protime 15.1 and 41 seconds], both recovered).
da Silveira EBV, Young K, Rodriguez M, Ameen N. (2002). Reye's syndrome in a 17-year-old male: is this disease really disappearing?. Dig Dis Sci. (17 year old boy took aspirin for febrile illness and presented with confusion 6 days later with ALT 1728 U/L, normal bilirubin; ultrasound showed fatty liver and biopsy showed microvesicular fat; recovered in 5 days).
Bhutta AT, Savell VH, Schexnayder SM. (2003). Reye's syndrome: down but not out. South Med J. (Case report of 3 year old boy given aspirin for fever presenting a few days later with encephalopathy and acute liver failure [bilirubin 1.1 mg/dL, AST 1060 U/L, Alk P 272 U/L, acidosis], liver biopsy showed microvesicular fat; patient had brain herniation and died: first case report from US in many years).
Chow EL, Cherry JD, Harrison R, McDiarmid SV, Bhuta S. (2003). Reassessing Reye Syndrome. Arch Pediatr Adolesc Med. (10 year old girl given aspirin for febrile illness developed confusion 2 days later [ALT 598 U/L, INR 1.9, ammonia 250 μmol/dL], liver biopsy showed microvesicular fat; ultimately suffered brain death).
Karademir S, Oğuz D, Senocak F, Ocal B, Karakurt C, Cabuk F. (2003). Tolmetin and salicylate therapy in acute rheumatic fever: Comparison of clinical efficacy and side-effects. Pediatr Int. (72 children with rheumatic fever were given tolmetin [n=20] or aspirin [n=52: 75-100 mg/kg/day] for 4-6 weeks; efficacy similar but side effects were more common with aspirin, ALT elevations [100-1000 U/L, but no jaundice] in 31% with aspirin vs 0% with tolmetin).
Lacroix I, Lapeyre-Mestre M, Bagheri H, Pathak A, Montastruc JL. (2004). Club de Reflexion des cabinets de Groupe de Gastro-Enterologie (CREGG).; General Practitioner Networks. Nonsteroidal anti-inflammatory drug-induced liver injury: a case-control study in primary care. Fundam Clin Pharmacol. (Case controlled study of cases of NSAID hepatotoxicity versus controls seen in a medical community care group in France, found 22 cases of NSAID induced hepatotoxicity among a total of 88 cases; including 7/88 attributable to aspirin, but 10/178 controls also taking aspirin; odds ratio=1.42; no clinical data given on cases).
van Bever HP, Quek SC, Lim T. (2004). Aspirin, Reye syndrome, Kawasaki disease, and allergies; a reconsideration of the links. Arch Dis Child. (Hypothesis linking rise in allergic diseases among children and decrease in use of aspirin: "It may not be too bold a postulate that this increase in allergic diseases might be due [at least in part] to the decreased use of ASA").
Wei C-M, Chen H-L, Lee P-I, Chen C-M, Ma C-Y, Hwu W-L. (2005). Reye's syndrome developing in an infant on treatment of Kawasaki syndrome. J Paediatr Child Health. (1 year old boy with Kawasaki syndrome was treated with IVIG and high dose aspirin and developed lethargy 2-3 days later with ALT 376 U/L, high ammonia, lactic acidosis and coagulopathy; given glucose and mannitol and recovered within a few days: liver biopsy showed microvesicular fat; no recurrence 2 years later, but no mention of restarting aspirin).
Ioi H, Kawashima H, Nishimata S, Watanabe Y, Yamanaka G, Kashiwagi Y, Yamada N, et al. (2006). A case of Reye syndrome with rotavirus infection accompanied with high cytokines. J Infect. (2 year old with diarrhea from rotavirus infection followed by coma and seizures with ALT 4136 U/L and hypoglycemia but no acidosis or jaundice biopsy showed fatty liver; ultimately recovered, did not take aspirin and possibility of metabolic disorder not fully investigated).
Glasgow JF. (2006). Reye's syndrome: the case for a causal link with aspirin. Drug Saf. (Systematic review of evidence linking aspirin ingestion to Reye syndrome; 6 case-control studies demonstrated significant increase in risk and 2 long-term prospective surveillance studies with 450 confirmed cases showed aspirin use in 59% of cases and 26% of controls, mortality rate 53%; marked decrease in numbers since 1996; cases without aspirin exposure may have inherited metabolic disease resembling Reye syndrome).
Schrör K. (2007). Aspirin and Reye syndrome: a review of the evidence. Paediatr Drugs. (Review article questioning the cause-and-effect relationship between aspirin intake and Reye syndrome and suggesting that the increase prevalence of asthma in children may relate to decrease in aspirin or increase in acetaminophen use).
Fitzgerald DA. (2007). Aspirin and Reye syndrome. Paediatr Drugs. (Editorial on controversy surrounding aspirin and Reye syndrome).
Jiménez-Caballero PE, Montes-Gonzalo MC, Velázquez-Pérez JM. (2008). Rev Neurol.
Gosalakkal JA, Kamoji V. (2008). Reye syndrome and Reye-like syndrome. Pediatr Neurol. (14 year old girl developed fever followed by vomiting and confusion having taken 3 doses of aspirin [325 mg each] 3 days earlier [ALT 80 U/L, ammonia 120 μmol/L, glucose 81 mg/dL, pH 7.34] and died 5 days later).
Pugliese A, Beltramo T, Torre D. (2008). Reye's and Reye's-like syndromes. Cell Biochem Funct. (Review of Reye syndrome and its differential diagnosis which includes congenital metabolic disorders of urea cycle, and fatty acid and glucose metabolism).
Ghosh A, Pradhan S, Swami R. (2008). K C SR, Talwar OP. Reye syndrome: a case report with review of literature. JNMA J Nepal Med Assoc. (3 year old Nepalese girl developed fever followed by vomiting and loss of consciousness [ALT 1270 U/L] and died 2 days later, autopsy showing hepatic microvesicular steatosis; no history of aspirin ingestion).
Beutler AI, Chesnut GT, Mattingly JC, Jamieson B. (2009). FPIN's Clinical Inquiries. Aspirin use in children for fever or viral syndromes. Am Fam Physician. (Addresses the question of the age at which aspirin is safe to use for viral syndromes or fever in children; rare cases have been reported in adults, and most recommendations are to not use aspirin below the age of 19 years).
Lemberg A, Fernández MA, Coll C, Rosello DO, Romay S, Perazzo JC, Filinger EJ. (2009). Reyes's syndrome, encephalopathy, hyperammonemia and acetyl salicylic acid ingestion in a city hospital of Buenos Aires, Argentina. Curr Drug Saf. (12 cases of Reye syndrome presented to a referral hospital in Buenos Aires between 1985 and 2000; ages 2 to 10 years, 6 boys, all with fever followed by vomiting and encephalopathy; all had taken aspirin [average ALT 302 U/L, glucose 35 mg/dL], 5 died).
Cağ M, Saouli AC, Audet M, Wolf P, Cinqualbre J. (2010). Reye syndrome and liver transplantation. Turk J Pediatr. (6 month old boy with fever and cough received a single dose of aspirin and rapidly developed seizures and coma with hypoglycemia [glucose 17 mg/dL, ALT 75 rising to 11,270 U/L], recovering with emergency auxiliary partial liver transplant; explant showing microvesicular steatosis and in follow up, the native liver recovered and so that immunosuppression could be withdrawn, but he had severe epilepsy and delayed psychomotor development in long term follow up).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to aspirin).
Ozsoylu S. (2011). Did the patient have Reye syndrome?. Turk J Pediatr. (Letter in response to Cağ [2010] suggesting that the patient had an inherited mitochondrial condition and Reye-like syndrome).
Whitten R, Milner DA, Yeh MM, Kamiza S, Molyneux ME, Taylor TE. (2011). Liver pathology in Malawian children with fatal encephalopathy. Hum Pathol. (Autopsy results on 87 Malawian children who died of fatal encephalopathy suspected to be due to cerebral malaria identified 9 with marked hepatic microvesicular steatosis with minimal necrosis suggestive of Reye syndrome, 6 of whom had a recent history of aspirin ingestion).
Link A, Kaplan BT, Böhm M. (2012). Dtsch Med Wochenschr. (21 year old woman developed coma shortly after recovering from influenza for which she took aspirin [bilirubin not given, ALT 548 U/L, INR 1.58, ammonia 358 μg/dL], with progressive neurologic deterioration and death).
Raza A, Vierling J, Hussain KB. (2013). Genetics of drug-induced hepatotoxicity toxicity in Gilbert's syndrome. Am J Gastroenterol. (55 year old man with elevated liver tests [bilirubin 1.4 mg/dL, ALT 219 U/L, Alk P 72 U/L] while taking an analgesic with aspirin [1.5 g/day] and acetaminophen [1.5 g/day], had Gilbert syndrome and was homozygous for the A(TA)7TAA promoter mutation).
Selves A, Ruiz S, Crognier L, Conil JM, Bonneville F, Georges B, Dupuy M, et al. (2013). Ann Fr Anesth Reanim. (19 year old man developed coma after receiving aspirin for viral pericarditis and died of cerebral edema, liver tests were minimally abnormal [bilirubin 1.2 mg/dL, ALT normal, AST 1.5 times ULN], serum ammonia and liver biopsy not available).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, Presentation and Outcomes in Patients with Drug-Induced Liver Injury in the General Population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to allopurinol).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to aspirin).
Laster J, Satoskar R. (2014). Aspirin-induced acute liver injury. ACG Case Rep J. (41 year old woman with pericarditis developed abdominal pain and marked elevations in serum aminotransferase levels 2 days after starting high doses of aspirin [bilirubin 0.8 mg/dL, ALT 5684 U/L, Alk P 84 U/L, INR 13.8], resolving rapidly upon stopping).
Shirota T, Ikegami T, Sugiyama S, Kubota K, Shimizu A, Ohno Y, Mita A, et al. (2015). Successful living donor liver transplantation for acute liver failure after acetylsalicylic acid overdose. Clin J Gastroenterol. (20 year old Japanese woman took an overdose of aspirin [66 grams] and developed liver and renal failure, pancreatitis and progressive coma, and was successfully treated with emergency liver donor left lobe transplantation).
Cao Z, Liu S, Niu J, Wei B, Xu J. (2015). Severe hepatoxicity caused by aspirin overdose: a case report. Front Med. (61 year old man took an overdose of aspirin [4 g] and developed gastrointestinal bleeding, fever, pneumonia, cholecystitis, pancreatitis and multiorgan failure [bilirubin peak 18.1 mg/dL, ALT 7790 U/L, Alk P not given], resolving over the following month).
Ahrens-Nicklas RC, Edmondson AC, Ficicioglu C. (2015). An 8-year-old girl with abdominal pain and mental status changes. Pediatr Emerg Care. (8 year old girl was treated with aspirin for suspected rheumatic fever and developed vomiting, diarrhea and progressive somnolence [bilirubin 0.7 mg/dL, ALT 2834 U/L, Alk P not given, INR 1.67, ammonia 161 μ mol/L, glucose 57 mg/dL], recovering in several days with conservative management).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to aspirin).

## OTHER REFERENCE LINKS

1 Recent References on Aspirin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=aspirin/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222009/5/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Aspirin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=aspirin)